# Heparin

## OVERVIEW

### Introduction

Standard or unfractionated heparin is a complex mixture of naturally occurring glycosaminoglycans and is used as an anticoagulant to treat venous thrombosis or to prevent thrombosis in high risk patients. Heparin therapy is associated with frequent elevations in serum aminotransferase levels that are typically transient and not associated with clinical symptoms or significant liver injury.

### Background

Heparin (hep' a rin) is a complex mixture of naturally occurring glycosaminoglycans that have potent anticoagulant activity. Heparin has been used to treat or prevent venous thromboses for more than 50 years. Multiple generic forms of heparin are available, usually in ampoules or vials of 1000 to 40,000 units per mL. Heparin is typically given initially as 5000 to 10,000 units intravenously, followed by intravenous or subcutaneous boluses every 4 to 12 hours to keep the activated partial thrombin time in the range of 1.5 to 2 times the control value. Common side effects of standard heparin include dizziness, fatigue, headache, indigestion, nausea, excess bleeding, ecchymoses, rash and urticaria.

### Hepatotoxicity

Heparin has been associated with transient serum aminotransferase elevations in 10% to 60% of patients, but values are usually less than 5 times the upper limit of normal and are rarely associated with symptoms or jaundice. Values above 5 times the upper limit of normal occur in ~2% of those receiving the high doses of heparin. In contrast, serum bilirubin and alkaline phosphatase levels usually do not change. The aminotransferase elevations are usually asymptomatic, mild and self-limited arising within the first 4 to 8 days of therapy and decreasing thereafter, rarely requiring dose modification or discontinuation. In the rare instances of mild, clinically apparent liver injury attributed to heparin reported in the literature, other possible causes of liver injury were usually present (shock, heart failure, sepsis, other potential hepatotoxins). The serum enzyme elevations generally resolve fully within 4 to 10 days of stopping heparin. Allergic features (rash, fever, eosinophilia) and autoantibodies are generally not present.

### Mechanism of Injury

The cause of the serum aminotransferase elevations during heparin therapy is not known, but it is likely due to a direct hepatotoxic effect on the liver. The elevations may be accompanied by decreases in platelet counts, another know side effect of heparin therapy.

### Outcome and Management

The serum aminotransferase elevations that occur on heparin therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No convincing instances of clinically apparent, severe acute liver injury have been linked to heparin therapy in the published literature.

References to hepatotoxicity of standard heparin and low molecular weight heparins are given at the end of the overview section entitled Heparins.

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass, Anticoagulants: Dabigatran, Desirudin, Apixaban, Edoxaban, Fondaparinux, Rivaroxaban, Heparins, Warfarin

Other Drugs in the Subclass, Heparins: Dalteparin, Enoxaparin, Tinzaparin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Heparin – Generic

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Heparin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Heparin | 9005-49-6 | Unspecified | No Structure

## OTHER REFERENCE LINKS

1. Recent References on Heparin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Heparin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Heparin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Heparin)